# Solriamfetol

## OVERVIEW

### Introduction

Solriamfetol is dopamine and norepinephrine reuptake inhibitor that is used in the therapy of excessive daytime sleepiness and cataplexy in patients with narcolepsy. Solriamfetol has not been associated with serum enzyme elevations during therapy or to instances of idiosyncratic acute liver injury.

### Background

Solriamfetol (sol”ri am’ fe tol) is an orally available, small molecule dopamine and norepinephrine reuptake inhibitor (DNRI) that is used to treat excessive daytime sleepiness in adults with narcolepsy or obstructive sleep apnea. Dopamine and norepinephrine are major stimulatory neurotransmitters and inhibition of their synaptic reuptake results in higher levels. Dysregulation of dopaminergic and norepinephrine systems plays at least a partial role in wakefulness and sleep. Narcolepsy is associated with a deficiency in orexin, a major mediator of wakefulness. Modulation of dopamine and norepinephrine signaling by solriamfetol increases wakefulness, independent of orexin and has been shown to improve wakefulness and decrease excessive daytime sleepiness in patients with narcolepsy as well as in patients with obstructive sleep apnea who have difficulty with daytime sleepiness. In several randomized, placebo controlled trials, solriamfetol was found to decrease sleepiness and increase wakefulness scores in the majority of treated subjects. Solriamfetol was approved in the United States in 2019 as therapy for excessive daytime sleepiness associated with narcolepsy and obstructive sleep apnea in adults. Solriamfetol is available tablets of 75 and 150 mg under the brand name Sunosi. The recommended initial dose is 75 mg once daily in adults with narcolepsy and 37.5 mg once daily in obstructive sleep apnea with subsequent titration to a maximum of 150 mg daily. Side effects can include headache, nausea, anxiety, irritability, insomnia, dizziness, palpitations, dry mouth and decreased appetite which are frequent during the titration period but often resolve with maintenance therapy. Nevertheless, up to 10% of patients discontinue therapy because of adverse events. Severe adverse events are rare, but solriamfetol can cause increase in blood pressure and heart rate which should be monitored during therapy. Solriamfetol is a Schedule IV controlled agent, indicating that it has the potential for dependence and abuse.

### Hepatotoxicity

In placebo-controlled trials of solriamfetol in patients with narcolepsy, minor serum aminotransferase elevations occurred in a small proportion of patients during therapy, but the rates of enzyme elevations overall were similar to those in placebo recipients. In preregistration trials, there were no instances of clinically apparent liver injury or serum aminotransferase elevations with jaundice attributable to solriamfetol. Since its approval in 2019, there have been no publications describing clinically apparent liver injury due to solriamfetol.

Likelihood score: E (unlikely cause of acute liver injury with jaundice).

### Mechanism of Injury

The mechanism by which solriamfetol might cause liver injury is not known. Its hepatic safety is probably due to the fact that it has little metabolism and is excreted largely unchanged (>95%) in the urine. Solriamfetol has minimal drug-drug interactions.

Drug Class: CNS Stimulants

Other Drugs for Narcolepsy: Amphetamines, Modafinil, Armodafinil, Methylphenidate, Oxybate, Pitolisant

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Solriamfetol – Sunosi®

DRUG CLASS

CNS Drugs

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Solriamfetol)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Solriamfetol | 178429-62-4 | C10-H14-N2-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 18 August 2021

Abbreviations: DNRI, dopamine and norepinephrine reuptake inhibitor.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of solriamfetol).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2019/211230Orig1Orig2s000RiskR.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA multidisciplinary scientific review of the solriamfetol application for safety and efficacy, which reported that the trials of solriamfetol had no fatalities and no treatment related serious hepatic adverse events).
Strollo PJ, Hedner J, Collop N, Lorch DG, Chen D, Carter LP, Lu Y, et al. (2019). Tones 4 Study Investigators. Solriamfetol for the treatment of excessive sleepiness in OSA: a placebo-controlled randomized withdrawal study. Chest. (Among 174 adults with obstructive sleep apnea and excessive daytime sleepiness treated with a dose titration of solriamfetol followed by randomization to continue therapy or switch to placebo, there was clinical improvement on drug and relapse upon withdrawal, adverse events occurring largely during the titration phase [total rate of 49% decreasing to 10.2% during maintenance]; no mention of ALT elevations or hepatotoxicity).
Thorpy MJ, Shapiro C, Mayer G, Corser BC, Emsellem H, Plazzi G, Chen D, et al. (2019). A randomized study of solriamfetol for excessive sleepiness in narcolepsy. Ann Neurol. (Among 231 patients with narcolepsy and excessive daytime sleepiness treated with solriamfetol [75, 150 or 300 mg] or placebo daily for 12 weeks, both higher doses were associated with improvements achieved within 1 week of starting and maintained thereafter, and while adverse events were more frequent with solriamfetol [68% vs 46%] as were discontinuations [5% to 8.5% vs 1.7%], “no drug-related effects were found on clinical laboratory assessments”).
Markham A. (2019). Solriamfetol: first global approval. Drugs. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy, and safety of solriamfetol shortly after its approval for use in the US, mentions the most common symptoms but does not mention ALT elevations or hepatotoxicity).
Schweitzer PK, Rosenberg R, Zammit GK, Gotfried M, Chen D, Carter LP, Wang H, et al. (2019). TONES 3 Study Investigators. Solriamfetol for excessive sleepiness in obstructive sleep apnea (TONES 3). A randomized controlled trial. Am J Respir Crit Care Med. (Among 459 adults with obstructive sleep apnea and excessive daytime sleepiness treated with solriamfetol [37.5, 75, 150 or 300 mg daily] or placebo for 12 weeks, sleepiness scores decreased and wakefulness scores increased, and while total adverse events were more common with solriamfetol, severe adverse events were rare [0.8% vs 1.7% in controls] and “laboratory evaluations did not indicate effects of clinical relevance related to solriamfetol”).
(2019). Solriamfetol (Sunosi) for excessive daytime sleepiness. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and cost of solriamfetol for excess sleepiness associated with narcolepsy and obstructive sleep apnea mentions adverse events of headache, nausea, anorexia, dry mouth, anxiety, and insomnia but does not discuss ALT elevations of hepatotoxicity).
Malhotra A, Shapiro C, Pepin JL, Hedner J, Ahmed M, Foldvary-Schaefer N, Strollo PJ, et al. (2020). Long-term study of the safety and maintenance of efficacy of solriamfetol (JZP-110) in the treatment of excessive sleepiness in participants with narcolepsy or obstructive sleep apnea. Sleep. (1 year extension study of solriamfetol in 643 patients who completed participation in 12-week placebo controlled trials found that the effects on excessive sleepiness were maintained, and adverse events being headache [11%], nausea [9%], insomnia [8%], dry mouth [7%], anxiety [7%], and anorexia [5%], with 9% discontinuing therapy because of adverse events; no mention of ALT elevations or hepatotoxicity).
Thorpy MJ. (2020). Recently approved and upcoming treatments for narcolepsy. CNS Drugs. (Review of the mechanism of action, pharmacology, drug-drug interactions, clinical efficacy and safety of newly approved medications for narcolepsy including pitolisant and solriamfetol; no mention of ALT elevations or hepatotoxicity).
Videnovic A, Amara AW, Comella C, Schweitzer PK, Emsellem H, Liu K, Sterkel AL, et al. (2021). Solriamfetol for Excessive Daytime Sleepiness in Parkinson's Disease: Phase 2 Proof-of-Concept Trial. Mov Disord. (Among 66 patients with Parkinson disease and excessive daytime sleepiness treated with 4 one-week courses of solriamfetol [75, 150, or 300 mg] or placebo once daily, “there were minor or no clinically meaningful changes in…clinical laboratory findings”).

## OTHER REFERENCE LINKS

1 Recent References on Solriamfetol: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Solriamfetol+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Solriamfetol: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Solriamfetol)